# Anesthetics, General

## OVERVIEW

General anesthetics depress the central nervous system adequately to allow for surgery or invasive, potentially painful, procedures. These are generally administered for a short period only and by medical personnel specifically trained in their use, efficacy and safety. General anesthetics can be separated into inhalational gases and parenterally admistered agents as well as on the basis of their structure and mechanisms of action.

Several general anesthetics have been implicated in causing liver injury, usually arising within 1 to 14 days of their administration. Most commonly implicated was halothane, the initial halogenated inhalational general anesthetic which was introduced into practice in the 1950's. Shortly thereafter, case reports followed by case series were published of severe liver injury attributed to halothane. The liver injury arose within days or a few weeks of the exposure and was typically associated with a hepatocellular pattern of injury accompanied by fever and signs of hypersensitivity. Halothane hepatitis was often severe and, although rare, led to a decrease in its use, particularly with the development of better tolerated and safer halogenated gases for anesthesia such as enflurane (1972), isoflurane (1981), desfurane (1993), and sevoflurane (1995). Drug induced liver injury can occur with the newer agents, but is extremely rare.

The other general anesthetics have not been definitely implicated in causing drug induced liver injury, at least when given in conventional anesthetic doses and for limited periods of time. Nitrous oxide, for instance, has not been convincingly linked to liver injury despite wide scale use for many decades. Two more recently developed anesthetics, however, have been implicated in causing unusual and rare forms of liver injury: propofol and ketamine.

Propofol, which has become the most common general anesthetic in general use, can cause a distinctive and life threatening syndrome (the "propofol infusion syndrome") when given for prolonged periods, a syndrome that can be accompanied by lactic acidosis and liver dysfunction. Ketamine can cause an unusual form of liver injury when used on a regular basis (as with ketamine abuse), marked by recurrent abdominal pain, biliary strictures and cholestatic liver injury.

Each of the general anesthetics is discussed separately with case examples and references.

Drug Class: Anesthetics, General

- Barbiturates
  - Amobarbital, Methohexital, Thiopental
- Halogenated
  - Desflurane, Enflurane, Halothane, Isoflurane, Sevoflurane
- Miscellaneous
  - Ketamine, Nitrous Oxide, Propofol